# Selective Estrogen Receptor Modulators

## OVERVIEW

### Introduction

The selective estrogen receptor modulators (SERMs) are a group of nonsteroidal compounds that have estrogen-like effects (agonism) on some tissues (such as bone, skin, heart or vaginal epithelium), but antiestrogen effects (antagonism) on other tissues (such as breast or uterus). Depending on the tissue specificity and balance of the agonist and antagonist activities, these agents have different clinical effects, different indications and different adverse side effects. Typical indications for SERMS include treatment or prevention of breast cancer (tamoxifen, toremifene, raloxifene), treatment or prevention of postmenopausal osteoporosis (raloxifene, bazedoxifene) and amelioration of symptoms of menopause symptoms (ospemifene). Separate documents for the SERMs that are used largely for prevention of cancer, tamoxifen and toremifene, are available in LiverTox. This document summaries background information and the potential hepatotoxicity of raloxifene, bazedoxifene and ospemifene, SERMs used for treatment of nonmalignant conditions such as osteoporosis and menopausal symptoms of hot flashes and dyspareunia.

Drug Class: Antineoplastic Agents, Osteoporosis Agents

### Raloxifene

#### Background

Raloxifene (ral ox' i feen) is a selective estrogen receptor modulator that has estrogen-like effects (agonism) on bone and the cardiovascular system but antiestrogen activity (antagonism) on breast and uterus tissue. This differential activity takes advantage of the beneficial effects of estrogens on bone in decreasing bone resorption and turnover and thus preventing osteoporosis, while avoiding the potential harmful effects of estrogen stimulation of breast and uterine tissue. In several large clinical trials, raloxifene was shown to increase bone mineral density and prevent bone fractures in postmenopausal women at high risk for osteoporosis, while decreasing serum cholesterol levels (both total and LDL) and without stimulating breast and uterine growth. Raloxifene was approved for treatment and prevention of postmenopausal osteoporosis in the United States in 1997, and indications were expanded in 2007 to include reduction of risk of breast cancer in postmenopausal women with osteoporosis as well as those at high risk of breast cancer. Raloxifene is available in tablets of 60 mg generically and under the brand name Evista, and the recommended dose is 60 mg daily. Side effects are not common, but can include hot flashes, leg cramps, peripheral edema, arthralgias and sweating. Rare, but potentially severe adverse events include deep venous thrombosis, pulmonary embolism and ischemic strokes, side effects that it shares with estrogen.

#### Hepatotoxicity

In large, prelicensure clinical trials, the rate of serum enzyme elevations during raloxifene therapy was less than 1% and was no higher than with placebo or comparator arms. In addition, no episodes of hepatitis or clinically apparent liver injury attributable to raloxifene were reported. In the two decades since its approval and wide scale use, there have been isolated reports of liver injury attributed to raloxifene. One report described a case of cholestatic hepatitis arising a month after starting raloxifene which resolved with stopping, but full recovery was delayed (Case 1). The injury was accompanied by mild immunoallergic features, but autoantibodies were not present. A second case of cholestatic hepatitis was reported in a patient on long term raloxifene who had been started on fenofibrate two weeks before the onset of jaundice. The injury was attributed to the combination of the two agents and possible drug-drug interactions. Finally, several cases of an exacerbation of nonalcoholic steatohepatitis during raloxifene therapy have been reported, a pattern of injury that has been reported more commonly with tamoxifen. Thus, raloxifene may be a rare cause of liver injury, but the relationship to the drug has not been very well established.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

#### Mechanism of Injury

The reason why raloxifene might cause liver injury is not known, but the isolated cholestatic cases appear to be due to an idiosyncratic hypersensitivity reaction. Raloxifene is metabolized in the liver by glucuronidation and it has minimal effects on cytochrome P450 enzymes (CYP).

#### Outcome and Management

Serum enzyme elevations are uncommon during raloxifene therapy and are rarely dose limiting. While clinically apparent liver injury with jaundice has been reported with raloxifene therapy, it is very rare. Evaluation should include assessment of hepatic steatosis by ultrasound or other imaging modalities. There is no known cross sensitivity to hepatic injury among the SERMs or with other agents for osteoporosis. On the other hand, restarting raloxifene after clinically apparent liver injury cannot be recommended.

Drug Class: Antineoplastic Agents, Osteoporosis Agents

## CASE REPORT

### Case 1. Immunoallergic cholestatic hepatitis due to raloxifene.

[Modified from: Vilches AR, Pérez V, Suchecki DE. Raloxifene-associated hepatitis. Lancet 1998; 352 (9139): 1524-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9820309)]

A 49 year old postmenopausal woman with osteoporosis developed fatigue and rash approximately one month after starting raloxifene and calcium for postmenopausal osteoporosis. She stopped her medications, but 5 days later developed jaundice and sought medical advice. She had no history of liver disease and had normal liver tests before starting raloxifene. On examination, she was jaundiced and had a mild, morbilliform rash. She did not have fever or signs of chronic liver disease. Laboratory tests showed total bilirubin of 6.2 mg/dL, ALT 291 U/L, AST 224 U/L, alkaline phosphatase 643 U/L and slightly elevated eosinophil counts (Table). Tests for hepatitis A, B and C were negative as were routine autoantibodies. Abdominal ultrasound showed no evidence of biliary obstruction or hepatic masses. Serum enzyme levels slowly improved, but bilirubin levels rose to a peak of 15.1 mg/dL. She developed pruritus, but eventually improved with resolution of jaundice and symptoms. Serum alkaline phosphatase levels, however, remained high.

#### Key Points

Medication: | Raloxifene (60 mg daily)
Pattern: | Cholestatic (R=1.6)
Severity: | 3+ (bilirubin elevation, hospitalization)
Latency: | 4-5 weeks
Recovery: | Partial at 18 weeks
Other medications: | None mentioned, except for calcium carbonate

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | Normal | Normal | Normal | Values not given
5 weeks | 5 days | 291 | 643 | 6.2 | Eosinophils 520/µL
2 months | 1 month | | | 15.1 | Pruritus
5 months | 4 months | 36 | 365 | 1.1 | Asymptomatic
Normal Values | | <35 | <120 | <1.2

#### Comment

This brief report described a woman with osteoporosis who developed a somewhat prolonged cholestatic hepatitis one month after starting raloxifene. The injury was accompanied by rash and eosinophilia suggestive of an immunoallergic hypersensitivity reaction. She was symptomatic for more than a month, and serum alkaline phosphatase levels were still 3 times the upper limit of normal four months after stopping the drug. Little else besides biliary tract disease could cause this clinical picture, and this report remains the most convincing report of clinically apparent liver injury from raloxifene.

## Bazedoxifene

### Background

Bazedoxifene (ba" ze dox' i feen) is a selective estrogen receptor modulator that is used to prevent osteoporosis in menopausal women and for treatment of moderate-to-severe vasomotor symptoms associated with menopause (hot flashes, sweating). Bazedoxifene has estrogen-like effects (agonism) on bone and the cardiovascular system, but antiestrogen activity (antagonism) on breast and uterus tissue. This differential activity is keyed to achieving the beneficial effects of estrogens on bone in decreasing bone resorption and turnover and thus preventing osteoporosis, but avoiding the potential harmful effects of estrogen stimulation of breast and uterine tissue. While bazedoxifene by itself is approved for use in several other countries of the world, in the United States it is approved only as a combination product with low doses of conjugated estrogens. In short term trials the combination of bazedoxifene and estrogens was shown to decrease menopause associated hot flushes. Longer term trials of this combination have documented its efficacy in preventing osteoporosis in postmenopausal women. The fixed combination of bazedoxifene (20 mg) and conjugated estrogens (0.45 mg) was approved for use in the United States under the brand name Duavee in 2013. Common side effects include muscle spasms, nausea, diarrhea, dyspepsia, dizziness and abdominal, throat and neck pain. Potential long term, severe adverse events include deep venous thrombosis, pulmonary embolism and ischemic strokes and the possible long term effects of estrogens such as increased risk of breast, endometrial and ovarian cancer and gallbladder disease.

### Hepatotoxicity

In large, prelicensure clinical trials, the rate of serum enzyme elevations during combination therapy with bazedoxifene and estrogens was no higher than with placebo or comparator arms, and no episodes of hepatitis or clinically apparent liver injury were reported. Since its approval and more wide spread use, there have been no published reports of clinically apparent liver injury associated with this combination product.

Likelihood score: E* (unlikely cause of clinically apparent liver injury, but suspected to be capable of causing the liver injury reported with other SERMs and estrogens).

### Mechanism of Injury

The reason why bazedoxifene might cause liver injury is not known, but its chemical structure is not unlike other SERMs that have been linked to idiosyncratic liver injury. While estrogens can be associated with a cholestatic liver injury arising soon after initiation of treatment, this typical syndrome has not been reported with bazedoxifene combined with conjugated estrogens, perhaps because of the low doses of estrogens used.

### Outcome and Management

Serum enzyme elevations are uncommon during bazedoxifene/estrogen therapy and have rarely required dose reduction. While clinically apparent liver injury with jaundice has not been reported with bazedoxifene therapy, it has been reported with other SERMs such as tamoxifen and raloxifene. There is no known cross sensitivity to hepatic injury among the SERMs.

Drug Class: Osteoporosis Agents

## Ospemifene

### Background

Ospemifene (os pem' i feen) is a selective estrogen receptor modulator that is used for the treatment of moderate-to-severe menopausal symptoms of dyspareunia such as vaginal atrophy, dryness, itching and irritation as well as pain on intercourse. Ospemifene has estrogen-like effects (agonism) on vaginal epithelium, but antiestrogen activity (antagonism) on breast tissue. This differential activity is keyed to achieving the beneficial effects of estrogens on vaginal secretions and epithelial integrity, while avoiding the potential harmful effects of estrogen stimulation of breast tissue. In several large clinical trials, ospemifene was shown to decrease symptoms of dyspareunia (vaginal dryness and discharge and pain on intercourse) without stimulating breast and uterine growth. Ospemifene was approved for treatment of moderate-to-severe symptoms of dyspareunia in postmenopausal women in the United States in 2013. It is not approved for treatment or prevention of osteoporosis. Ospemifene is available in tablets of 60 mg under the brand name Osphena and the recommended dose is 60 mg daily. Long term therapy is not recommended. Side effects are not common, but can include hot flashes, muscle spasms, vaginal discharge and sweating. Rare, but potentially severe long term adverse events include deep venous thrombosis, pulmonary embolism and ischemic strokes.

### Hepatotoxicity

In large, prelicensure clinical trials, the rate of serum enzyme elevations during ospemifene therapy was no higher than with placebo or comparator arms. In addition, no episodes of hepatitis or clinically apparent liver injury were reported in these studies. While ospemifene has had only limited widescale use, it has not been linked to episodes of liver injury in the published literature or to the cholestatic hepatitis that has been linked to other SERMs such as tamoxifen and raloxifene.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why ospemifene might cause liver injury is not known, but isolated idiosyncratic cases of cholestatic hepatitis have been linked to therapy with other SERMs. Ospemifene is metabolized in the liver by glucuronidation and has minimal effects on cytochrome P450 (CYP) enzyme activity.

### Outcome and Management

Serum enzyme elevations are uncommon during ospemifene therapy and are rarely dose limiting. There is no known cross sensitivity to hepatic injury among the SERMs.

Drug Class: Hormonal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Raloxifene – Generic, Evista®

Bazedoxifene with Conjugated Estrogens – Duavee®

Ospemifene – Osphena®

DRUG CLASS

(Raloxifene) Antineoplastic Agents; Osteoporosis Agents

(Bazedoxifene) Osteoporosis Agents

(Ospemifene) Hormonal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Raloxifene)

(Raloxifene) Product labeling at DailyMed, National Library of Medicine, NIH

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bazedoxifene)

(Bazedoxifene) Product labeling at DailyMed, National Library of Medicine, NIH

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ospemifene)

(Ospemifene) Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Raloxifene | 84449-90-1 | C28-H27-N-O4-S | Raloxifene chemical structure
Bazedoxifene | 198481-32-2 | C6-H13-N-O5 | Bazedixufene chemical structure
Ospemifene | 128607-22-7 | Unspecified | Ospemifene chemical structure
Tamoxifen | 10540-29-1 | C26-H29-N-O | Tamoxifen Chemical Structure
Toremifene | 89778-26-7 | C26-H28-Cl-N-O | Toremifene chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 21 September 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 mentions that tamoxifen can lead to cholestasis, peliosis hepatis, fatty liver, steatohepatitis and cirrhosis, and that raloxifene was implicated in at least one case of hepatotoxicity).
Chitturi S, Farrell GC. Estrogen receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of estrogen receptor antagonists discusses tamoxifen and toremifene, but not raloxifene, bazedoxifene or ospemifene).
Moy B, Lee RJ, Smith M. Anti-estrogen therapy. Natural products in cancer chemotherapy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1756-9. (Textbook of pharmacology and therapeutics).
Raloxifene for postmenopausal osteoporosis. Med Lett Drugs Ther 1998; 40 (1022): 29-30. (Concise summary of the mechanism of action, clinical efficacy, safety, drug interactions and costs of raloxifene shortly after its approval in the United States for postmenopausal osteoporosis, mentions side effects of hot flashes and leg cramps and the risk of venous thrombosis and fetal abnormalities; no mention of ALT elevations or hepatotoxicity). 9529516
Toremifene and letrozole for advanced breast cancer. Med Lett Drugs Ther 1998; 40 (1024): 43-5. (Concise summary of the clinical efficacy and side effects of toremifene and letrozole shortly after their approval in the United States as therapies for invasive breast cancer, mentions that side effects of toremifene are similar to those of tamoxifen and that ALT elevations can occur). 9580744
Vilches AR, Pérez V, Suchecki DE. Raloxifene-associated hepatitis. Lancet 1998; 352 (9139): 1524-5. (49 year old woman with osteoporosis developed cholestatic hepatitis 1 month after starting raloxifene [bilirubin 6.2 mg/dL, ALT 2913 U/L, Alk P 643 U/L, mild eosinophilia], resolving slowly and incompletely by four months after stopping: Case 1). 9820309
Cummings SR, Eckert S, Krueger KA, Grady D, Powles TJ, Cauley JA, Norton L, et al. The effect of raloxifene on risk of breast cancer in postmenopausal women: results from the MORE randomized trial. Multiple Outcomes of Raloxifene Evaluation. JAMA 1999; 281: 2189-97. (Among 7705 postmenopausal women with osteoporosis treated with raloxifene [60 or 120 mg] or placebo daily for 3 years, raloxifene decreased the risk of invasive breast cancer, but increased the risk of venous thrombosis, and side effects included hot flushes, leg cramps and venous thrombosis; no mention of ALT elevations or hepatotoxicity). 10376571
Hamada N, Ogawa Y, Saibara T, Murata Y, Kariya S, Nishioka A, Terashima M, et al. Toremifene-induced fatty liver and NASH in breast cancer patients with breast-conservation treatment. Int J Oncol 2000; 17: 1119-23. (Among 52 women with breast cancer treated with toremifene for 3 to 5 years, 4 [8%] developed fatty liver disease by CT scan, 2 with raised ALT and AST levels and one with steatohepatitis on liver biopsy). 11078796
Drugs for prevention and treatment of postmenopausal osteoporosis. Med Lett Drugs Ther 2000; 42 (1090): 97-100. (Concise summary of the clinical efficacy and adverse effects of drugs for postmenopausal osteoporosis, including raloxifene and bazedoxifene with conjugated estrogens). 11035622
Martino S, Cauley JA, Barrett-Connor E, Powles TJ, Mershon J, Disch D, Secrest RJ, et al.; CORE Investigators. Continuing outcomes relevant to Evista: breast cancer incidence in postmenopausal osteoporotic women in a randomized trial of raloxifene. J Natl Cancer Inst 2004; 96: 1751-61. (Among 4011 women with high risk of breast cancer treated with raloxifene or placebo for up to 8 years, total as well as serious adverse events and discontinuations because of adverse events were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 15572757
Barrett-Connor E, Mosca L, Collins P, Geiger MJ, Grady D, Kornitzer M, McNabb MA, et al.; Raloxifene Use for The Heart (RUTH) Trial Investigators. Effects of raloxifene on cardiovascular events and breast cancer in postmenopausal women. N Engl J Med 2006; 355: 125-37. (Among 10,101 postmenopausal women with risk factors of coronary artery disease treated with raloxifene or placebo for an average of 5.6 years, coronary artery events were similar in both groups, but breast cancer rates were lower with raloxifene; adverse events included hot flushes [8% vs 5%], leg cramps [10% vs 7%], peripheral edema [14% vs 12%] and gall bladder disease [5.6% vs 4.5%]; no mention of ALT elevations or hepatotoxicity). 16837676
Vogel VG, Costantino JP, Wickerham DL, Cronin WM, Cecchini RS, Atkins JN, Bevers TB, et al.; National Surgical Adjuvant Breast and Bowel Project (NSABP). Effects of tamoxifen vs raloxifene on the risk of developing invasive breast cancer and other disease outcomes: the NSABP Study of Tamoxifen and Raloxifene (STAR) P-2 trial. JAMA 2006; 295: 2727-41. (Among 19,747 postmenopausal women with high risk for breast cancer treated with either tamoxifen [20 mg daily] or raloxifene [60 mg daily] for an average of 5 years, invasive breast and uterine cancer rates were similar as were numbers of osteoporotic fractures; no mention of ALT elevations or clinically apparent liver disease). 16754727
Raloxifene (Evista) for breast cancer prevention in postmenopausal women. Med Lett Drugs Ther 2006; 48 (1234): 37. (Concise summary of the clinical efficacy, safety and costs of raloxifene shortly after its approval in the United States for prevention of breast cancer, mentions that venous thromboses were lower with raloxifene than tamoxifen; no mention of ALT elevations or hepatotoxicity). 16685245
Lucena MI, Andrade RJ, Vicioso L, González FJ, Pachkoria K, García-Muñoz B. Prolonged cholestasis after raloxifene and fenofibrate interaction: A case report. World J Gastroenterol 2006; 12: 5244-6. (60 year old woman with osteoporosis developed jaundice two weeks after starting fenofibrate and while on chronic raloxifene therapy [bilirubin 11.1 rising to 21.8 mg/dL, ALT 241 U/L, Alk P 174 U/L], resolving slowly and incompletely with persistent Alk P elevations two years later [bilirubin 0.8 mg/dL, ALT 60 U/L, Alk P 444 U/L]). 16937543
Takamura T, Shimizu A, Komura T, Ando H, Zen Y, Minato H, Matsushita E, Kaneko S. Selective estrogen receptor modulator raloxifene-associated aggravation of nonalcoholic steatohepatitis. Intern Med 2007; 46: 579-81. (53 year old woman with postmenopausal osteoporosis and mild serum enzyme elevations attributed to fatty liver disease developed more marked enzyme elevations within a few months of starting raloxifene [bilirubin not given, ALT rising from 82 to 356 U/L, Alk P from 199 to 414 U/L] despite little weight gain, biopsy showing bridging fibrosis and steatohepatitis and values falling to baseline after stopping raloxifene). 17473493
Miller PD, Chines AA, Christiansen C, Hoeck HC, Kendler DL, Lewiecki EM, Woodson G, et al. Effects of bazedoxifene on BMD and bone turnover in postmenopausal women: 2-yr results of a randomized, double-blind, placebo-, and active-controlled study. J Bone Miner Res 2008; 23: 525-35. (Among 1434 postmenopausal women with osteoporosis treated with 3 doses of bazedoxifene [10, 20 or 40 mg] or placebo daily for 2 years, adverse events usually attributed to bazedoxifene included hot flushes [20-24% vs 14%], leg cramps [9-12% vs 11.6%] and venous thrombosis [0.0-0.6% vs 0.3%); no mention of ALT elevations or hepatotoxicity or deaths from liver disease). 18072873
Silverman SL, Christiansen C, Genant HK, Vukicevic S, Zanchetta JR, de Villiers TJ, Constantine GD, et al. Efficacy of bazedoxifene in reducing new vertebral fracture risk in postmenopausal women with osteoporosis: results from a 3-year, randomized, placebo-, and active-controlled clinical trial. J Bone Miner Res 2008; 23: 1923-34. (Among 6847 postmenopausal women with osteoporosis treated for 3 years, new vertebral fractures were less with bazedoxifene and raloxifene compared to placebo, but hot flushes, leg cramps and venous thromboses were more frequent; no mention of ALT elevations or clinically apparent liver injury). 18665787
Pinkerton JV, Utian WH, Constantine GD, Olivier S, Pickar JH. Relief of vasomotor symptoms with the tissue-selective estrogen complex containing bazedoxifene/ conjugated estrogens: a randomized, controlled trial. Menopause 2009; 16: 1116-24. (Among 332 postmenopausal women with hot flushes treated with bazedoxifene/estrogens or placebo for 12 weeks, hot flushes decreased with active therapy by 74-80% and with placebo by 54%; adverse event rates were similar in the all groups; no mention of ALT levels or hepatotoxicity). 19546826
Bachmann GA, Komi JO; Ospemifene Study Group. Ospemifene effectively treats vulvovaginal atrophy in postmenopausal women: results from a pivotal phase 3 study. Menopause 2010; 17: 480-6. (Among 826 postmenopausal women with vulvo-vaginal atrophy treated with ospemifene [30 or 60 mg] or placebo daily for 12 weeks, symptoms of vaginal dryness and dyspareunia improved most with the higher dose of ospemifene, and adverse events were similar in the three groups except for hot flushes [9.6% and 8.3% vs 3.4%] and “all laboratory and safety parameters remained at essentially the same levels throughout the study”). 20032798
Matsumura M, Tashiro K, Miura A, Tajima T, Kinoshita I, Kojima E, Yoshizawa A. [A case of non-alcoholic fatty liver disease (NAFLD) aggravated after treatment with raloxifene]. Nihon Shokakibyo Gakkai Zasshi 2011; 108 (12): 2036-41. Japanese. (70 year old woman with osteoporosis and nonalcoholic fatty liver developed worsening liver test abnormalities within 3 months of starting raloxifene [bilirubin 0.4 mg/dL, ALT rising from 30-50 to 154 U/L, Alk P 422 U/L], biopsy showing NASH and fibrosis, ALT improving upon stopping raloxifene and starting ursodiol). 22139492
Silverman SL, Chines AA, Kendler DL, Kung AW, Teglbjærg CS, Felsenberg D, Mairon N, et al.; Bazedoxifene Study Group. Sustained efficacy and safety of bazedoxifene in preventing fractures in postmenopausal women with osteoporosis: results of a 5-year, randomized, placebo-controlled study. Osteoporos Int 2012; 23: 351-63. (In a 2 year extension of a 3 year study of 2 doses of bazedoxifene vs placebo in 4216 postmenopausal women with osteoporosis, adverse events were similar in the 3 groups except for hot flushes, leg cramps and deep venous thrombosis [0.5% and 0.6% vs 0.2%]; no mention of ALT elevations or hepatotoxicity). 21779819
Palacios S, de Villiers TJ, Nardone Fde C, Levine AB, Williams R, Hines T, Mirkin S, et al.; BZA Study Group. Assessment of the safety of long-term bazedoxifene treatment on the reproductive tract in postmenopausal women with osteoporosis: results of a 7-year, randomized, placebo-controlled, phase 3 study. Maturitas 2013; 76: 81-7. (Among 1301 women with osteoporosis treated with bazedoxifene or placebo for up to 7 years, serious adverse events and breast, endometrial and ovarian complications were similar in the two groups; no mention of ALT elevations or clinically apparent liver injury). 23871271
Simon JA, Lin VH, Radovich C, Bachmann GA; Ospemifene Study Group. One-year long-term safety extension study of ospemifene for the treatment of vulvar and vaginal atrophy in postmenopausal women with a uterus. Menopause 2013; 20: 418-27. (Among 180 postmenopausal women with vulvar and vaginal atrophy treated with ospemifene or placebo for up to one year, side effects more common with ospemifene included hot flashes and vaginal candidiasis or mycotic infections; no mention of ALT elevations or clinically apparent liver injury). 23096251
Ospemifene (Osphena) for dyspareunia. Med Lett Drugs Ther 2013; 55 (1420): 55-6. (Concise summary of the mechanism of action, clinical efficacy, safety, drug interactions and costs of ospemifene shortly after its approval in the US for postmenopausal dyspareunia, mentions side effects of hot flashes, vaginal discharge, muscle spasms and sweating; no mention of ALT elevations or hepatotoxicity). 23836373
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25,1425. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to a selective estrogen receptor modulator). 23419359
Pinkerton JV, Harvey JA, Lindsay R, Pan K, Chines AA, Mirkin S, Archer DF; SMART-5 Investigators. Effects of bazedoxifene/conjugated estrogens on the endometrium and bone: a randomized trial. J Clin Endocrinol Metab 2014; 99: E189-98. (Among 1843 postmenopausal women receiving bazedoxifene/estrogens, bazedoxifene alone, estrogens/progesterone or placebo for at least 12 months, bone density improved with bazedoxifene and estrogens, but not placebo treatment and side effects were less with bazedoxifene with estrogens than with estrogens with progestins; no mention of ALT elevations or hepatotoxicity). 24438370
Conjugated estrogens/bazedoxifene (Duavee) for menopausal symptoms and prevention of osteoporosis. Med Lett Drugs Ther 2014; 56 (1441): 33-4. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of estrogens, bazedoxifene and the combination of the two shortly after approval of the combination in the United States for prevention of postmenopausal osteoporosis, mentions that side effects are similar to those with placebo; no mention of ALT elevations or hepatotoxicity). 24759293
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 4 cases were attributed to tamoxifen but none were attributed to raloxifene, toremifene or other selective estrogen receptor modulators). 25754159
Ellis AJ, Hendrick VM, Williams R, Komm BS. Selective estrogen receptor modulators in clinical practice: a safety overview. Expert Opin Drug Saf 2015; 14: 921-34. (Review of the safety of SERMs focusing upon breast, uterine and cardiovascular adverse events; no mention of ALT elevations or liver disease). 25936229

## OTHER REFERENCE LINKS

1. Recent References on Raloxifene, Bazedoxifene, Ospemifene: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Raloxifene+Bazedoxifene+Ospemifene/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Raloxifene, Bazedoxifene, Ospemifene: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Raloxifene+Bazedoxifene+Ospemifene)